# Probenecid

## OVERVIEW

### Introduction

Probenecid is a uricosuric agent used for the treatment of gout usually in combination with other agents. Probenecid has been associated with minor serum aminotransferase elevations and very rarely with hypersensitivity reactions which, even more rarely, can be accompanied by acute liver injury.

### Background

Probenecid (proe ben' e sid) is a sulfonamide derivative that acts as an inhibitor of inorganic acid transport in the distal renal tubule, causing blockage of reabsorption of uric acid. Therapy leads to lowering of serum uric acid levels within a few weeks, and chronic therapy has been shown to decrease uric acid levels and to decrease acute gouty attacks. Probenecid also inhibits the excretion of penicillin and other drugs and has been used as an adjunct to penicillin therapy to increase plasma drug levels. Probenecid was approved for use in the United States in 1951 and is still used for therapy and prevention of gout and hyperuricemia. Probenecid is available in tablets of 500 mg in several generic forms and under brand names such as Benemid and Benuryl, as well as in fixed combinations with colchicine. The recommended initial dose for gout is 250 to 500 mg twice a day, which can be increased to 2 g daily based upon target levels of uric acid. Probenecid is typically used in combination with other agents for gout, such as colchicine. Common side effects include headache, gastrointestinal upset, hypersensitivity reactions and transient worsening of gout.

Probenecid is also used in combination with penicillin and penicillin derivatives (such as ampicillin and nafcillin) to prolong their plasma half-life and increase serum concentrations. The typical dose for this effect is 1 g daily. Importantly, however, probenecid has similar effects on many other medications, inhibiting the tubular secretion and increasing serum concentrations of drugs such as acetaminophen, naproxen, indomethacin, ketoprofen, lorazepam and rifampin. Thus, patients taking probenecid should be cautioned about use of other medications.

### Hepatotoxicity

There are no reports on the frequency of liver test abnormalities during probenecid therapy, but they are probably rare as the drug is largely secreted unchanged in the urine. A single case report of a severe hypersensitivity reaction from probenecid and rechallenge with a rapid and severe recurrence of jaundice was reported over 50 years ago. As is typical for hypersensitivity reactions, the onset was within days of starting probenecid and was accompanied by fever and rash.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of probenecid hepatotoxicity is probably hypersensitivity. Most cases of hypersensitivity to probenecid are marked by skin rash alone, without liver damage.

### Outcome and Management

Chronic hepatitis and vanishing bile duct syndrome have not been reported from probenecid therapy. Hypersensitivity reactions (largely rash and urticaria) to probenecid can occur and rechallenge should be avoided as the single case of severe liver injury reported was in a patient who was retreated with probenecid after a prolonged hypersensitivity reaction to a previous exposure.

Drug Class: Antigout Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Probenecid – Generic, Benemid®

DRUG CLASS

Antigout Agents/Gout Suppressants

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=probenecid)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Probenecid | 57-66-9 | C13-H19-N-O4-S

## ANNOTATED BIBLIOGRAPHY

References updated: 10 July 2020

Zimmerman HJ. Drugs used to treat gout. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 543-4. (Textbook of hepatotoxicity published in 1999; mentions that probenecid has effects on indocyanine green [ICG] and sulfobromophthalein [BSP] excretion, but rarely causes liver injury; despite years of use only a single case report of severe hypersensitivity with jaundice has been published).
Grosser T, Smyth EM, FitzGerald GA. Pharmacotherapy of inflammation, fever, pain, and gout. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 685-710. (Textbook of pharmacology and therapeutics).
Reynolds ES, Schlant RC, Gonick HC, Dammin GJ. (1957). Fatal massive necrosis of the liver as a manifestation of hypersensitivity to probenecid. N Engl J Med. (57 year old man developed fever, rash, eosinophilia and jaundice 2 days after starting probenecid, with slow recovery upon withdrawal and recurrence of fever and jaundice upon restarting, whereupon drug was continued for 10 days when he was admitted with acute liver failure; autopsy showed massive necrosis and portal inflammation without fibrosis).
Hillecke NA. (1965). Acute anaphylactoid reaction to probenecid. JAMA. (61 year old man developed anaphylaxis after single dose of colchicine-probenecid with leukemoid reaction, hypotension and fever, recovering within a week; rechallenge with probenecid without colchicine resulted in recurrence of anaphylaxis [bilirubin not given, AST 80 U/L]).
Vogin EE, Scott W, Boyd J, Bear WT, Mattis PA. (1966). Effect of probenecid on indocyanine green clearance. J Pharmacol Exp Ther. (In beagles, probenecid caused a reversible and dose related inhibition of indocyanine green excretion and increase in bile flow, probably due to its known effects on membrane transport).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to probenecid).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to probenecid).

## OTHER REFERENCE LINKS

1 Recent References on Probenecid: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Probenecid/AE+AND+Human%5BMH%5D+AND+(drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222010/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Probenecid: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Probenecid)